# Phenyltoloxamine

## OVERVIEW

### Introduction

Phenyltoloxamine is a first generation antihistamine that is used for symptoms of the common cold and as a short acting sedative. Phenyltoloxamine has not been linked to instances of clinically apparent acute liver injury.

### Background

Phenyltoloxamine (fen" il tol ox' a meen) is a first generation antihistamine that is used to treat the symptoms of the common cold, including sneezing, cough, runny note, watery eyes and itching. Because of its sedating side effects, it is also used as a mild sleeping aid and sedative. Phenyltoloxamine belongs to the ethanolamine class of antihistamines (with clemastine and dimenhydrinate) and is currently used largely in combination with other agents such as phenylephrine and acetaminophen in over-the-counter products for relief of symptoms of the common cold and nighttime relief of minor aches and pains. Representative brand names of products that include phenyltoloxamine include Dologesic and Relagesic. The typical adult oral dose is 30 to 50 mg. Common side effects include sedation, impairment of motor function, confusion, dizziness, blurred vision, dry mouth and throat, palpitations, tachycardia, abdominal distress, constipation and headache. Antihistamines can worsen urinary retention and glaucoma.

### Hepatotoxicity

Like most first generation antihistamines, phenyltoloxamine has not been linked to liver test abnormalities or to clinically apparent liver injury. The reason for its safety may relate its short half-life and limited duration of use.

References on the safety and potential hepatotoxicity of antihistamines are given together after the Overview section on Antihistamines.

Likelihood score: E (unlikely to be a cause of clinically apparent liver injury).

Drug Class: Antihistamines

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Phenyltoloxamine – Dologesic®, Relagesic®

DRUG CLASS

Antihistamines

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Phenyltoloxamine)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Phenyltoloxamine | 92-12-6 | C17-H21-N-O | Phenyltoloxamine Chemical Structure

## OTHER REFERENCE LINKS

1. Recent References on Phenyltoloxamine: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Phenyltoloxamine/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Phenyltoloxamine: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Phenyltoloxamine)